# Triazolam

## OVERVIEW

### Introduction

Triazolam is an orally available benzodiazepine used predominantly for therapy of insomnia. As with most benzodiazepines, triazolam has not been associated with serum aminotransferase or alkaline phosphatase elevations during therapy, and clinically apparent liver injury from triazolam has been reported but is very rare.

### Background

Triazolam (trye az" oh lam) is a benzodiazepine that was widely used as a sleeping aid in the therapy of insomnia for several decades but is now rarely used. The soporific activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA A receptor. Triazolam was approved in the United States in 1982 and rapidly became the most common prescription sleeping pill used in the United States. Concerns over its safety led to its withdrawal from use in the UK, and the availability of other potent, shorter acting sleeping pills has caused its decrease in general use in the United States. Current indications are limited to short-term management of insomnia. Triazolam is available in multiple generic forms and under the brand name Halcion in tablets of 0.125 and 0.25 mg. The recommended initial dose for adults is 0.125 mg immediately before bedtime, increasing to 0.25 as needed; rarely, higher doses are used. The most common side effects of triazolam are dose related and include daytime drowsiness, lethargy, ataxia, dysarthria and dizziness. Tolerance develops to these side effects, but tolerance may also develop to the soporific effects. Triazolam has been linked to complex sleep related behaviors without consciousness, confusion, hallucinations, and with anterograde amnesia, having difficulty forming new memories. Triazolam like all oral benzodiazepines has a boxed warning in its product label stressing (1) the risks of severe sedation and potentially fatal respiratory depression when combined with opiates, (2) with prolonged use, the risks of abuse, misuse, and addiction which can lead to overdose and death, and (3) the risks of dependence with continued use and severe potentially life-threatening withdrawal symptoms if discontinued suddenly. Benzodiazepines are all categorized as Schedule IV controlled substances, having potential for dependence, tolerance, and abuse.

### Hepatotoxicity

Triazolam, like other benzodiazepines, is rarely associated with serum ALT and alkaline phosphatase elevations, and clinically apparent liver injury from triazolam is rare. There have been no well described case reports of acute liver injury from triazolam, except for a single report of severe and prolonged cholestatic liver injury ultimately leading to death from hepatic failure. Isolated single cases of clinically apparent cholestatic liver injury have been reported with other benzodiazepines including alprazolam, chlordiazepoxide, clonazepam, diazepam, flurazepam, lorazepam, and triazolam. The clinical pattern of acute liver injury from benzodiazepines is typically self-limited in course, mild-to-moderate in severity and with a latency of 1 to 6 months. Fever and rash are uncommon as is autoantibody formation.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Triazolam is metabolized by the liver to inactive metabolites that are excreted in the urine. Liver injury from benzodiazepines is probably due to a rarely produced intermediate metabolite. The relative safety of triazolam is probably related to its low daily dose (<1 mg).

### Outcome and Management

The case reports of hepatic injury due to benzodiazepines were followed by prompt and complete recovery upon stopping the medication, without evidence of residual or chronic injury. A single case of liver failure due to prolonged cholestatic hepatitis after triazolam therapy has been described in the literature. There is no information about cross reactivity with other benzodiazepines, but some degree of cross sensitivity should be assumed.

Drug Class: Sedatives and Hypnotics, Benzodiazepines

## CASE REPORT

### Case 1. Severe cholestatic liver injury attributed to triazolam.(1)

A 44 year old man developed jaundice approximately 4 months after starting triazolam (0.25 mg nightly) for insomnia which he took 2 to 3 times per week. He had a history of ampullary carcinoma of the pancreas that had been successfully resected 6 years before. A month before the onset of jaundice, he developed atrial fibrillation and was treated with digoxin, hydrochlorothiazide and amiloride. He had no history of liver disease. On presentation, one month after onset of symptoms of jaundice, he was found to have bilirubin of 10.6 mg/dL, AST 97 U/L and Alk P 104 U/L. A percutaneous cholangiogram showed no evidence of biliary obstruction and subsequent laparotomy revealed no cause for the jaundice. A liver biopsy showed intrahepatic cholestasis. He was discharged but continued to worsen and was readmitted several weeks later with progressive hepatic failure. Autopsy showed no biliary obstruction and liver histology again revealed severe intrahepatic cholestasis without cirrhosis.

#### Comment

Cholestatic hepatitis is typical of the few cases of clinically apparent liver injury that have been linked to benzodiazepine use. The current case, however, is distinctive for the severe and relentless degree of cholestasis. There was no mention of bile duct damage, but the course is not incompatible with rapidly evolving vanishing bile duct syndrome. As stated by the authors, the attribution of the liver injury to triazolam is conjectural. The intermittent use and low doses (less than 1 mg per week) make it an unlikely or only possible cause.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Triazolam – Generic, Halcion®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=triazolam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Triazolam | 28911-01-5 | C17-H12-Cl2-N4

## CITED REFERENCES

1 Cobden I, Record CO, White RWB. (1981). Fatal intrahepatic cholestasis associated with triazolam. Postgrad Med J.

## ANNOTATED BIBLIOGRAPHY

References updated: 24 January 2017

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999; mentions rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate and clotiazepam, but no reports of hepatic injury with lorazepam, oxazepam or temazepam).
Larrey D, Ripault MP. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455. (Review of drug induced liver injury mentions that rare instances of acute liver injury [usually cholestatic] have been reported with alprazolam, clonazepam, chlordiazepoxide, diazepam, flurazepam and triazolam).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-53. (Textbook of pharmacology and therapeutics).
Cobden I, Record CO, White RWB. (1981). Fatal intrahepatic cholestasis associated with triazolam. Postgrad Med J. (44 year old man developed jaundice after 5 months of intermittent triazolam therapy for insomnia [bilirubin 10.6 mg/dL, AST 97 U/L and Alk P 104 U/L]; jaundice deepened and patient died, autopsy showed intrahepatic cholestasis without obstruction or cirrhosis: Case 1).
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. (1985). Gastroenterol Clin Biol. (Review of hepatotoxicity of anticonvulsants; among benzodiazepines, cases of cholestatic hepatitis have been linked to chlordiazepoxide and diazepam, but liver injury from this class of drugs is exceptionally rare).
Hindmarch I, Fairweather DB, Rombaut N. (1993). Adverse events after triazolam substitution. Lancet. (Survey of UK physicians, one year after withdrawal of triazolam in the UK, found higher rate of adverse reactions [largely CNS] with replacements such as temazepam, loprazolam, nitrazepam, and lormetazepam, but no mention of hepatotoxicity).
Lewis JH, Zimmerman HJ. (1999). Drug- and chemical-induced cholestasis. Clin Liver Dis. (Review of drug induced cholestatic syndromes, listing many causes including chlordiazepoxide and flurazepam; “Benzodiazepines may cause cholestatic injury, although this is rare”).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 20 were attributed to benzodiazepines including 5 for clorazepate, 5 alprazolam, 6 lorazepam and 4 diazepam, but compared to controls, relative risk of injury was increased only for clorazepate [8.3: estimated frequency 3.4 per 100,000 person-year exposures]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none attributed to a benzodiazepine).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to a benzodiazepine).
(2012). Drugs for insomnia. Treat Guidel Med Lett. (Guidelines for therapy of insomnia mentions that benzodiazepines are controlled substances and when used for sleep may impair next day performance).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to triazolam or any other benzodiazepine, despite the fact that millions of prescriptions for them are filled yearly).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to a benzodiazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to triazolam or any other benzodiazepine).
(2023). Drugs for chronic insomnia. Med Lett Drugs Ther. (Concise review of drugs for chronic insomnia mentions that tolerance and dependence can occur with use of benzodiazepines and their use should be discouraged, and that benzodiazepines are CNS suppressants and can impair next day performance including driving and cause complex behavior disorders, retrograde amnesia, dependence, tolerance, abuse and rebound insomnia; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Triazolam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Triazolam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Triazolam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Triazolam)